# Diltiazem

## OVERVIEW

### Introduction

Diltiazem hydrochloride is a first generation calcium channel blocker that is widely used in the therapy of hypertension and angina pectoris. Diltiazem therapy is associated with serum enzyme elevations and has been linked to rare instances of clinically apparent liver injury.

### Background

Diltiazem (dil tye' a zem) belongs to the benzothiazepine class of calcium channel blockers and is used for the treatment of hypertension, angina pectoris and superventricular tachyarrhythmias. Like other calcium channel blockers, diltiazem acts by inhibiting the transmembrane influx of calcium ions into cardiac muscle and vascular smooth muscle cells. The inhibition of calcium flux causes arterial vasodilation and decreases cardiac work and oxygen consumption. Diltiazem, like verapamil (but unlike other calcium channel blockers), also decreases the rate of the sinus node pacemaker and slows atrial-ventricular conduction accounting for its effects on superventricular tachyarrhythmias. Diltiazem was approved in the United States in 1982 and currently several million prescriptions are filled yearly. Current indications for oral forms of diltiazem include hypertension and management of chronic stable angina pectoris, Prinzmetal's or variant angina. Diltiazem is available orally in multiple generic formulations as well as under commerical names including Cardizem and Tiazac in capsules of 30, 60, 90 and 120 mg. Once daily, extended release formulations are available and now widely used (Cardizem CD, Cardizem LA, Cartia XT, Dilacor XR, Dilt-XR, Diltia XT, Taztia XT) in strengths ranging from 60 to 420 mg. The recommended oral dose of diltiazem in adults is 180 to 360 mg daily, usually starting with lower doses. Chronic therapy is typical. Diltiazem is also available in intravenous formulations which are used in therapy of atrial arrhythmias, including atrial fibrillation or flutter and superventricular tachycardia. Diltiazem, like other calcium channel blockers, is generally well tolerated and side effects are due to its vasodilating activities and can include dizziness, flushing, headaches, fatigue, nausea, diarrhea, palpitations, bradycardia, postural hypotension and rash. Rare but potentially severe adverse events include cardiac conduction defects, hypotension, hypersensitivity reactions and instances of Stevens Johnson syndrome.

### Hepatotoxicity

Diltiazem therapy is associated with a low rate of mild and transient elevations in serum aminotransferase levels which are usually asymptomatic and often resolve even with continuation of therapy. Clinically apparent, acute liver injury with jaundice due to diltiazem is rare and only isolated case reports have been published. In large case series of drug induced liver injury, calcium channel blockers are rarely mentioned. Most cases attributed to diltiazem have been marked by a short latency period (3 to 14 days) and features of hypersensitivity with fever, rash and eosinophilia. The pattern of liver injury was ranged from cholestatic to hepatocellular. Jaundice is often absent and usually mild. Autoantibody formation has not been described. Thus, liver injury from diltiazem is likely to be idiosyncratic in nature and is typically mild and self-limited with resolution within 4 to 8 weeks of stopping. Acute hepatic injury is listened as a possible adverse event in the diltiazem product label.

Likelihood score: C (probable but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of diltiazem hepatotoxicity is not known, but most cases are probably due to hypersensitivity. Diltiazem is metabolized by the cytochrome P450 system and is an inhibitor of CYP 3A4 activity, which can lead to serious drug-drug interactions and potentiation of the hepatotoxic effects of other medications. Indeed, there have been several reports of clinically apparent liver injury or rhabdomyolysis occuring in patients on long term statins who had recently added diltiazem to their multidrug regimen, suggesting altered metabolism of the statin by the addition of a CYP 3A4 inhibitor.

### Outcome and Management

Severity of liver injury from diltiazem ranges from mild and transient serum enzyme elevations to self-limited hepatitis with jaundice. Complete recovery is expected after stopping the drug and recovery is usually rapid (1 to 2 months). Diltiazem has not been implicated in cases of chronic liver injury or vanishing bile duct syndrome, but was the suspected agent in at least one published case of acute liver failure. Cross sensitivity of liver injury with other calcium channel blockers has been described, but not with diltiazem.

Drug Class: Cardiovascular Agents, Antihypertensive Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Felodipine, Isradipine, Nicardipine, Nifedipine, Nimodipine, Nisoldipine, Verapamil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diltiazem – Generic, Cardizem®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=diltiazem)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Diltiazem | 42399-41-7 | C22-H26-N2-O4-S | Diltiazem chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999 mentions that among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers mentions that diltiazem and verapamil have been implicated in causing cholestatic liver injury in a small number of patients).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
McGraw BF. Diltiazem hydrochloride. Drug Intell Clin Pharm 1982; 16: 366-70. (Review of structure, chemistry, pharmacology, mechanism of action, clinical efficacy and safety of diltiazem; neither hepatotoxicity or ALT elevations are discussed in the section on adverse reactions). 7044735
Sawai K. Effects of long-term administration of diltiazem hydrochloride in hypertensive patients. Clin Ther 1983; 5: 422-35. (Analysis of side effects in 8 patients with hypertension treated with diltiazem for up to 5 years; there were no significant changes in ALT or AST levels during treatment). 6871924
Poulain D, Guimbail P, Florent F. [Median- and long-term tolerability of diltiazem]. Therapie 1984; 39: 177-84. French. (Among 162 patients with hypertension treated with diltiazem for 6-18 months, 3 [1.8%] had transient elevations in aminotransferase levels). 6729767
Scolnick B, Brinberg D. Diltiazem and generalized lymphadenopathy. Ann Intern Med 1985; 102: 558. (50 year old man developed lymphadenopathy 4 days after starting diltiazem followed by rash and fever with normal liver tests initially which later rose [bilirubin 0.4 mg/dL, ALT 250 U/L, 6% eosinophils], symptoms resolving within a month of stopping). 3156549
Sarachek NS, London RL, Matulewicz TJ. Diltiazem and granulomatous hepatitis. Gastroenterology 1985; 88: 1260-2. (54 year old man developed headache, fever and liver test elevations 2 weeks after starting diltiazem [bilirubin normal, ALT 254 U/L, Alk P 384 U/L, 3% eosinophils, liver biopsy showing granulomas], resolving within 3 weeks of stopping). 3979751
Shallcross H, Padley SP, Glynn MJ, Gibbs DD. Fatal renal and hepatic toxicity after treatment with diltiazem. Br Med J 1987; 295:1236-7. (72 year old man developed rash followed by renal failure 2 days after switching from nifedipine to diltiazem, followed by jaundice and multiorgan failure [bilirubin not given, ALT 2500 U/L, Alk P not given] and death 1 week later). 3120959
Buckley MM, Grant SM, Goa KL, McTavish D, Sorkin EM. Diltiazem. A reappraisal of its pharmacological properties and therapeutic use. Drugs 1990; 39: 757-806. (Review of pharmacology, clinical efficacy and safety of diltiazem; no mention of liver related side effects or effect on ALT levels). 2191851
Toft E, Vyberg G, Therkelsen K. Diltiazem-induced granulomatous hepatitis. Histopathology 1991; 18: 474-5. (68 year old woman developed fever and fatigue 2 weeks after starting diltiazem [bilirubin not given, AST 94 U/L, Alk P 1331 U/L, liver biopsy showing granulomas], resolving within 5 weeks of stopping). 1885169
Traverse JH, Swenson LJ, McBride JW. Acute hepatic injury after treatment with diltiazem. Am Heart J 1994; 127: 1636-9. (74 year old woman with angina developed sudden increase in liver tests [bilirubin 1.0 mg/dL, ALT 605 U/L, Alk P 60 U/L, LDH 990 U/L] 2 days after switching from nifedipine to diltiazem, with subsequent acidosis, hypoxia and hypotension, ultimately recovering and enzymes falling to normal within 10 days of stopping). 8197999
Weir MR. Diltiazem: ten years of clinical experience in the treatment of hypertension. J Clin Pharmacol 1995; 35: 220-32. (Review of efficacy and safety of diltiazem in hypertension; adverse events leading to drug discontinuation occurred in 45 to 5% of patients taking diltiazem in randomized controlled trials; no details of liver related adverse events provided). 7608309
Claas SA, Glasser SP. Long-acting diltiazem HCl for the chronotherapeutic treatment of hypertension and chronic stable angina pectoris. Expert Opin Pharmacother 2005; 6: 765-76. (Review of safety and efficacy of diltiazem; adverse events are reported to be no more frequent with diltiazem than with placebo; no hepatic adverse events were mentioned). 15934903
Schroeder JS, Beier-Scott L, Ginsburg R, Bristow MR, McAuley BJ. Efficacy of diltiazem for medically refractory stable angina: long-term follow up. Clin Cardiol 1985; 8: 480-5. (Among 31 patients treated with diltiazem for 8 to 47 months, 5 had transient enzyme elevations and 3 had chronic asymptomatic elevations). 2864152
Kanathur N, Mathai MG, Byrd RP Jr, Fields CL, Roy TM. Simvastatin-diltiazem drug interaction resulting in rhabdomyolysis and hepatitis. Tenn Med 2001; 94 (9): 339-41. (53 year old man developed nausea and fatigue 2 months after adding diltiazem to a chronic regimen of simvastatin [bilirubin 2.4 mg/dL, ALT 1707 U/L, Alk P 330 U/L, CPK 1390 U/L, myoglobin in the urine, protime 23 seconds], with resolution within 10 days of stopping both drugs). 11550401
Lewin JJ 3rd, Nappi JM, Taylor MH. Rhabdomyolysis with concurrent atorvastatin and diltiazem. Ann Pharmacother 2002; 36: 1546-9. (60 year old man developed fatigue and abdominal pain 3 weeks after adding diltiazem to a drug regimen that included atorvastatin with rhabdomyosis and liver test abnormalities [bilirubin 0.7 mg/dL, ALT 1610 U/L, Alk P 287 U/L, CPK 1898 U/L] that resolved within 3 months of stopping both drugs). 12243603
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker--felodipine). 16165719
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to a calcium channel blocker). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a calcium channel blocker or other antihypertensive medication). 23419359
Deng W, Farricielli L. Hypoxic hepatitis and acute liver failure in a patient with newly onset atrial fibrillation and diltiazem infusion. BMJ Case Rep 2013; 2013. pii: bcr2013200573. (70 year old man with symptomatic atrial fibrillation developed hypotension 15 hours after starting intravenous diltiazem followed by transient severe liver injury [bilirubin 2.3 mg/dL, ALT 3472 U/L, Alk P not given, creatinine 4.4 mg/dL, and platelets 51,000/uL], resolving rapidly upon stopping suggestive of ischemic hepatitis). 24042208
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to diltiazem or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances], but none to diltiazem). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Diltiazem: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=diltiazem/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Diltiazem: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=diltiazem)